# Asparaginase

## OVERVIEW

### Introduction

Asparaginase is a bacterial enzyme that is used as an antineoplastic agent, largely in the therapy of acute lymphocytic leukemia (ALL). Asparaginase has many side effects, one of which is hepatic injury that is characterized by inhibition of hepatic protein synthesis, marked cholestasis and steatosis, which is usually reversible but can be severe and lead to death from hepatic failure.

### Background

Asparaginase (as par' a jin ase), often referred to as L-asparaginase, is a bacterial enzyme that acts to decrease tissue stores of asparagine, a secondary amino acid that is important in the growth of many cancers. Asparaginase, prepared from E. coli, was introduced into cancer chemotherapy over 50 years ago and remains an important agent in the therapy of acute lymphocytic leukemia. Asparaginase has activity against other cancer types but is rarely used for other indications. Asparaginase was first approved for use in the United States in 1972 as an anticancer agent, with initial preparations being prepared from E. coli. Pegylated formulations of E. coli-derived asparaginase (pegaspargase) became available and were approved for use in 1994 and are currently available under the brand name Oncaspar. Another form of pegylated asparaginase referred to as calaspargase pegol (brand name Asparlas) was approved in 2018 as therapy of ALL in children and young adults (ages 1 month to 21 years). These preparations can be given every two (pegaspargase) or three (calaspargase) weeks and have largely replaced standard asparaginase. Asparaginase made from other bacteria (Erwinia chrysanthemi) was approved for use in the United States in 2011 under the brand name Erwinaze, and a recombinant form was originally approved in 2021 under the brand name Rylaze. Standard asparaginase is given either by intramuscular injection or, more typically, intravenous injection in doses of 25,000 IU/m^2^ three times weekly in 14-day cycles. Pegaspargase can also be given intramuscularly or intravenously, typically in a dose of 2500 IU/m^2^ every two or three weeks. Both standard and pegylated asparaginase are usually given in combination with other antineoplastic agents such as vincristine, mercaptopurine, methotrexate, daunorubicin, and prednisone. Asparaginase has many dose related toxicities including nausea, fever, hypersensitivity reactions (urticaria, wheezing), clotting abnormalities, bone marrow suppression, pancreatitis, hepatotoxicity and central nervous system toxicities.

### Hepatotoxicity

Some abnormalities of liver test results occur in almost all patients treated with either asparaginase or pegaspargase. Most typical is a decrease in serum albumin and clotting factors (including II, V, VII, VIII, IX, prothrombin and fibrinogen) due to inhibition of hepatic protein synthesis. Most patients also have a rise in alkaline phosphatase levels and a lower proportion have increases in serum aminotransferase levels and bilirubin. Symptoms of fatigue and anorexia may be present. The inhibition of clotting factor and thrombolytic activity rarely results in excess bleeding, but paradoxically can also cause excessive clotting and a hypercoagulable state. Serum aminotransferase elevations during asparaginase therapy are mild-to-moderate in severity (2 to 10 times the upper limit of normal) and self-limiting. The abnormalities typically arise after 2 to 3 weeks of therapy and resolve within 2 to 4 weeks of stopping.

Asparaginase and pegasparase can also result in a more severe and protracted form of liver injury marked by fatigue, dark urine and jaundice arising 2 to 3 weeks after starting the enzyme infusions and often between courses of therapy. The hepatic dysfunction is accompanied by hepatic steatosis which can be severe and accompanied by jaundice, hepatomegaly and evidence of hepatic failure (somnolence, coma, ascites). Imaging of the liver shows hepatomegaly and marked fat accumulation arising within a few weeks of starting the agent and sometimes after a single dose. Autoimmune and immunoallergic features are uncommon. The course of illness varies. Recovery tends to be slow, jaundice resolving in 2 to 8 weeks and serum enzymes thereafter. Deaths due to asparaginase hepatotoxicity have been reported but are rare (Case 1). The frequency of this clinically apparent liver injury after asparginase therapy is estimated to be 15% to 20% in adults but less than 5% in children. Furthermore, the rate of severe hepatic injury from asparaginase has been less frequent in recent years, perhaps due to safer dosage regimens, more purified preparations of the bacterial enzyme, better monitoring and dose adjustments based upon better understanding of pharmacokinetics. Nevertheless, the frequency of hepatotoxicity appears to be similar with standard and pegylated forms of asparaginase. Risk factors for clinically apparent liver injury include higher doses, older age and preexisting obesity, hyperlipidemia and diabetes. Although of unproven benefit, therapy with L-carnitine and vitamin B is often recommended. Interestingly, in many instances asparaginase therapy is tolerated after recovery from the acute episode with either no or milder liver injury (Case 2). Switching from an E. coli to an Erwinia chrysanthemi-derived asparaginase may also be less likely to induce a recurrence of hepatic injury.

The clinical features of hepatic injury due to asparaginase can be overshadowed by its other systemic toxicities, including severe nausea and vomiting, weakness, edema, pancreatitis and encephalopathy. Although hypersensitivity reactions to asparaginase are common (it is a bacterial not a human enzyme), these usually occur early before the appearance of liver injury and the hepatic injury is rarely accompanied by fever or eosinophilia or autoantibody formation.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Asparaginase is directly toxic to hepatocytes resulting in inhibition of protein synthesis and export of lipoproteins and lipids, with resultant steatosis and hepatic dysfunction. As with other forms of direct hepatotoxicity, the liver injury attributed to asparaginase arises rapidly, is dose related, and is rarely accompanied by with immunological features. The mechanism of the direct injury is not clear but may be the result of substrate depletion of asparagine or possibly arginine (as a consequence of argininase activity in the bacterial enzyme preparation). In animal models, asparaginase causes similar hepatic injury to that in humans. Hepatic injury with Erwinia-derived asparaginase may be less common than with E. coli-derived enzyme, but head-to-head comparisons have not been made.

### Outcome and Management

Asparaginase is typically given in 14 or 28 day cycles while pegaspargase is given at two-week intervals, and consequently the hepatic injury may first become clinically apparent after the drug is stopped. Further use of asparaginase (with dose reduction) should be delayed until hepatic function has been restored. Patients receiving asparaginase should be monitored for hepatic function and the drug stopped or dose adjusted if liver test abnormalities arise. Once clinically apparent liver injury arises, supportive clinical care and treatment of complications are essential. Anecdotal reports suggest that intravenous infusions of L-carnitine (50 mg/kg daily in divided doses for 5 to 8 days or until the injury resolves) and vitamin B preparations may be helpful. The efficacy of L-carnitine in ameliorating or preventing hepatic injury from asparaginase has not been shown in prospective controlled trials, but the approach appears to be safe and without serious adverse effects. In animal models, L-carnitine ameliorates the hepatic injury induced by asparaginase as do infusions of arginine.

Drug Class: Antineoplastic Agents

## CASE REPORTS

### Case 1. Severe hepatic injury and death due to asparaginase.(1)

A 68 year old man with acute lymphocytic leukemia was treated with induction chemotherapy using daunorubicin, vincristine, methotrexate, asparaginase, cyclophosphamide and prednisone. Mild liver test abnormalities were present even before therapy but rose precipitously between day 19 and 26 of therapy. Chemotherapy was stopped. Serum bilirubin was 10.9 mg/dL, ALT 122 U/L and alkaline phosphatase 480 U/L (Table). A liver biopsy showed diffuse microvesicular steatosis with minimal inflammation, necrosis or fibrosis. Several days later, he became progressively somnolent and was transferred to the intensive care unit. Serum ammonia levels were high (227 µmol/L; normal <35), but lactate and glucose levels were normal. He developed progressive coma, sepsis, renal failure and died 54 days after starting therapy and 4 weeks after stopping all chemotherapy.

#### Key Points

Medication: | Asparaginase (dose not given)
Pattern: | Cholestatic (R=0.7)
Severity: | 5+ (jaundice, hepatic failure and death)
Latency: | 26 days
Recovery: | None
Other medications: | Chemotherapy for leukemia included prednisone, daunorubicin, vincristine, methotrexate, and cyclophosphamide.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | pre | 50 | 159 | 2.4 | Started chemotherapy
5 days | | 144 | 141 | 0.8
11 days | | 182 | 110 | 1.0
19 days | | 124 | 64 | 1.0
26 days | 0 | 122 | 480 | 10.9 | Chemotherapy stopped
28 days | 2 days | 111 | 588 | 11.9 | Liver biopsy
32 days | 6 days | 132 | 982 | 19.5 | Somnolence
42 days | 16 days | 526 | 2735 | 20.9 | Coma
50 days | 24 days | 184 | 2688 | 32.0
54 days | 28 days | Died of hepatic and multiorgan failure
Normal Values | | <38 | <107 | <1.2

#### Comment

While this patient was receiving 6 chemotherapeutic agents concurrently, the hepatic injury most closely resembled asparaginase hepatotoxicity, which typically arises after 2 to 3 weeks of therapy and is marked by gradual elevations in alkaline phosphatase to high levels with variable increases in serum bilirubin and aminotransferase levels. Some cases are severe and associated with hepatomegaly, fatty metamorphosis, severe hepatic dysfunction, progressive jaundice and hepatic coma. The condition can progress for several weeks after stopping therapy and rare fatal instances such as the current case have been described. Complicating factors in this case were age and possibly preexisting liver disease. Asparaginase toxicity is not idiosyncratic, but there appears to be variable susceptibility to the injury, and risk factors include dose, age, obesity and preexisting diabetes. Early in the course, the fatty metamorphosis may be largely microvesicular steatosis, whereas later, a mixed or fully macrovesicular steatosis may be present. Unlike the acute fatty liver with hepatic failure that occurs with Reye syndrome and mitochondrial injury due to nucleoside analogues, the steatosis and liver injury associated with asparaginase is less commonly associated with lactic acidosis, hyperammonemia and hypoglycemia, although it can be accompanied by pancreatitis. Unlike the fatty liver that occurs with alcoholic and nonalcoholic liver disease (NASH), there is little ballooning degeneration, Mallory bodies or sinusoidal fibrosis.

### Case 2. Liver injury due to pegaspargase with recurrence on re-exposure.(2)

A 33 year old woman with acute lymphocytic leukemia was treated with induction chemotherapy using daunorubicin, vincristine, methotrexate, cytarabine, prednisone, and pegaspargase. Routine liver tests were normal before starting chemotherapy. Pegaspargase was given as a single intravenous infusion of 2520 IU on day 4. She developed symptoms of fatigue, weakness, nausea, and poor appetite a week after the pegaspargase infusion. Her symptoms persisted, and two weeks later she noted dark urine and jaundice and was found to have abnormal liver tests. Serum bilirubin was 8.4 mg/dL, ALT 1076 U/L and alkaline phosphatase 314 U/L (Table). Serum albumin was 1.5 g/dL and INR 1.1. All chemotherapy was stopped, and she was hospitalized. An abdominal ultrasound showed changes suggestive of hepatic steatosis but no evidence of biliary obstruction or gall stones. Tests for hepatitis A, B and C were negative. She had low levels of ANA (1:80), but SMA and AMA were negative, and immunoglobulin levels were normal. She was monitored on no therapy. Liver tests began to improve, and chemotherapy was restarted. A single infusion of pegaspargase was given and a few weeks later she again developed fatigue and dark urine and liver tests rose: bilirubin from 0.8 to 3.8 mg/dL, ALT from 47 to 533 U/L, and Alk P from 194 to 1018 U/L. Chemotherapy was held and liver tests improved once again. In follow up, chemotherapy was restarted with addition of mercaptopurine instead of pegaspargase. Eight months later she was in remission and all liver tests were normal.

#### Key Points

Medication: | Pegaspargase
Pattern: | Hepatocellular (R=14.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 21 days
Recovery: | Recurrence with re-exposure, ultimate complete recovery 8 months later
Other medications: | Chemotherapy for leukemia included prednisone, daunorubicin, vincristine, methotrexate, and cytarabine.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | pre | 46 | 76 | 0.6 | Started chemotherapy
4 days | -20 days | | | | Pegaspargase given iv
9 days | -14 days | 66 | 70 | 1.7 | Onset of symptoms
23 days | 0 | 1076 | 193 | 8.4 | Hospitalization
26 days | 3 days | 2331 | 314 | 12.8 | Ultrasound: steatosis
30 days | 7 days | 1112 | 420 | 3.0 | Discharged
5 weeks | 13 days | 217 | 218 | 2.3 | Chemotherapy restarted
| 16 days | 200 | 183 | 1.5
7 weeks | 4 weeks | 57 | 126 | 1.3 | Pegaspargase given iv
2 months | 5 weeks | 47 | 193 | 1.2
| 6 weeks | 67 | 194 | 0.8
| 7 weeks | 533 | 1018 | 3.8 | Fatigue and dark urine
| 7.5 weeks | 294 | 780 | 1.6
3 months | 8 weeks | 191 | 416 | 0.9
| 11 weeks | 57 | 163 | 0.5 | Mercaptopurine started
4 months | 3 months | 76 | 133 | 0.7
| 4 months | 56 | 119 | 0.3
9 months | 8 months | 37 | 92 | 0.6 | In remission
Normal Values | | <50 | <125 | <1.2

#### Comment

This patient developed typical asparaginase hepatotoxicity starting within a week of starting chemotherapy and with peak levels of enzyme elevations and jaundice 3 weeks after the single infusion of pegaspargase. Also typical was the fall in serum protein levels and marked hepatic steatosis. A liver biopsy was not done but asparaginase hepatotoxicity was suspected. Once it was clear that she was recovering, chemotherapy was restarted, and she was given another infusion of pegaspargase. Two weeks later she was again symptomatic and jaundiced, this second episode being somewhat less severe than the first. Unlike with immunoallergic forms of idiopathic drug induced liver injury, rechallenge with asparaginase often causes a less severe recurrence and can be mild and subclinical. Because of the importance of asparaginase in treatment of acute leukemia, attempts are often made to restart the agent despite a severe episode of hepatotoxicity. Rechallenge with asparaginase should be done cautiously, perhaps with a lower dose or a different formulation (such as Erwinia chrysanthemi derived asparaginase).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Asparaginase – Erwinaze®

Asparaginase (recombinant) – Rylaze®

Pegaspargase – Oncaspar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Asparaginase) [Asparaginase]

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Asparaginase | 9015-68-3 (https://pubchem.ncbi.nlm.nih.gov/substance/135362876) | Large protein | Unavailable
Pegaspargase | 130167-69-0 (https://pubchem.ncbi.nlm.nih.gov/substance/135352519) | Large protein | Unavailable

## CITED REFERENCES

1 Bodmer M, Sulz M, Stadlmann S, Droll A, Terracciano L, Krähenbühl S. Fatal liver failure in an adult patient with acute lymphoblastic leukemia following treatment with L-asparaginase. Digestion 2006; 74: 28-32.16988508
2 Kamal N, Koh C, Samala N, Fontana RJ, Stolz A, Durazo F, Hayashi PH, et al.; Drug-Induced Liver Injury Network. Asparaginase-induced hepatotoxicity: rapid development of cholestasis and hepatic steatosis. Hepatol Int. 2019;13:641-648. [Case #6] 31392570

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2023

Abbreviations: ALL, acute lymphocytic leukemia.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of neoplastic agents published in 1999; mentions high incidence of hepatic and pancreatic side effects from asparaginase, liver injury marked by steatosis which is found in 50-90% of patients and worsens with duration of treatment).
DeLeve L. L-asparaginase. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 557. (Review of hepatotoxicity of anticancer drugs states that the rate of liver test abnormalities and clinically apparent liver injury due to asparaginase therapy is considerably lower in the recent literature, although severe cases are still reported).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics; mentions that the toxicity of asparaginase is due to its antigenicity and to its actions in inhibiting protein synthesis).
Haskell CM, Canellos GP, Leventhal BG, Carbone PP, Block JB, Serpick AA, Selawry OS. L-asparaginase: therapeutic and toxic effects in patients with neoplastic disease. N Engl J Med 1969; 281: 1028-34. (Early experience with asparaginase in 55 patients with cancer or leukemia, given iv for 3 weeks; common side effects were nausea, fever, hypersensitivity reactions, clotting abnormalities, pancreatitis and CNS toxicity; the most frequent side effect was liver dysfunction characterized by decreases in serum albumin and slight elevations in Alk P, ALT and bilirubin; in one instance liver injury was severe). 4898857
Gross MA, Speer RJ, Hill JM. Hepatic lipidosis associated with L-asparaginase treatment. Proc Soc Exp Biol Med 1969; 130: 733-6. (Study in mice given different doses of asparaginase with different degrees of purity; highest purity samples had little hepatotoxicity). 5773660
Pratt CB, Simone JV, Zee P, Aur RJ, Johnson WW. Comparison of daily versus weekly L-asparaginase for the treatment of childhood acute leukemia. J Pediatr 1970; 77: 474-83. (Comparison of daily versus weekly infusions of asparaginase in 19 children with acute leukemia; evidence of hepatotoxicity occurred in all patients with decrease in albumin in 68%, increase in AST in 63%, Alk P in 16%, bilirubin in 47%, liver changes found on autopsies were "vacuolization of hepatocytes"). 5278225
Leventhal BG, Skeel RT, Yankee RA, Henderson ES. L-asparaginase (NSC- 09229) plus azaserine (NSC-742) in acute lymphatic leukemia. Cancer Chemother Rep 1970; 54: 47-51. (Result of use of asparaginase and azaserine in 27 children with acute lymphocytic leukemia; hypersensitivity reactions occurred in 33%, Alk P elevations in 77%, decreases in albumin in 59%, clotting abnormalities in 88%). 4945997
Oettgen HF, Stephenson PA, Schwartz MK, Leeper RD, Tallai L, Tan CC, Clarkson BD, et al. Toxicity of E. coli L-asparaginase in man. Cancer 1970; 25: 253-78. (Analysis of toxicity of asparaginase in 131 children and 143 adults with neoplastic disease; elevations in Alk P occurred in 31-47% of patients, AST in 46-63%, bilirubin in 29-51%, and decreases in albumin in 71-82%, usually arising during the 2nd to 3rd week of therapy and resolving upon stopping; fatty metamorphosis found in 73% of autopsies). 4905153
Bernard J, Jacquillat C, Boiron M, Weil M, Bussel A, Larrieu MJ, Delobel J, et al. [Treatment of acute leukemia with the L-asparaginase. Preliminary results based on 84 cases]. Presse Med. 1970; 78: 161-6. French. (Analysis of results of treating 75 patients with acute leukemia with asparaginase; liver toxicity was frequent and marked by falls in serum albumin and cholesterol with rises in Alk P, while ALT elevations were rare; two patients developed hepatic insufficiency which may have contributed to their deaths).
Burchenal JH. A summary of the clinical status of asparaginase. Recent Results Cancer Res 1970; 33: 350-4. (Summary of a workshop on asparaginase). 5292724
Jacquillat C, Weil M, Bussel A, Loisel JP, Rouesse T, Larrieu MJ, Boiron M, et al. Treatment of acute leukemia with L-asparaginase--preliminary results on 84 cases. Recent Results Cancer Res 1970; 33: 263-78. (Among 84 patients with acute leukemia given asparaginase, early toxicities included hypersensitivity reactions [fever, urticaria and anaphylaxis], and late toxicities where often hepatic with weight loss and elevations in bilirubin, Alk P [50%] and ALT [36%], with decrease in albumin [60%], cholesterol [72%] and fibrinogen, usually arising after the first week of therapy and beginning to resolve within a week of stopping). 5292720
Marmont AM, Damasio EE. Some clinical observations on the treatment with L-asparaginase of the acute leukemias. Recent Results Cancer Res 1970; 33: 296-315. (Discussion of side effects of asparaginase: "there can be no doubt that L-ase profoundly affects the liver cell"). 4949165
Carbone PP, Haskell CM, Leventhal BG, Block JB, Selawry OS. Clinical experience with L-asparaginase. Recent Results Cancer Res 1970; 33: 236-43. (Summary of results using asparaginase, similar to report by Haskell [1969]). 4949163
Zubrod CG. The clinical toxicities of L-asparaginase in treatment of leukemia and lymphoma. Pediatrics 1970; 45: 555-9. (Review of toxicities of asparaginase, hepatic abnormalities being the most common). 5438160
Beard ME, Crowther D, Galton DA, Guyer RJ, Fairley GH, Kay HE, Knapton PJ, et al. L-asparaginase in treatment of acute leukaemia and lymphosarcoma. Br Med J 1970; 1 (5690): 191-5. (Among 40 patients treated with L-asparaginase, nausea and vomiting were common as were "slight abnormalities in liver function tests"). 4904933
Pratt CB, Johnson WW. Duration and severity of fatty metamorphosis of the liver following L-asparaginase therapy. Cancer 1971; 28: 361-4. (Analysis of liver histology from autopsies in 31 children after asparaginase therapy, 27 [87%] had fatty metamorphosis for periods of up to 261 days after last dose, severity decreasing 60 days after dosing, but fatty change also found in 51% of children with leukemia who did not receive asparaginase). 5109448
Biggs JC, Chesterman CN, Holliday J. L-asparaginase--clinical experience in leukaemia, lymphoma and carcinoma. Aust N Z J Med 1971; 1: 1-7. (Among 11 patients with leukemia or cancer treated with asparaginase, mild elevations in ALT and Alk P [2-4 times ULN] occurred in 4).
Revol L, Fière D, Guyon JM. [Accidents due to asparaginase]. J Med Lyon 1971; 52: 831-3. French. 5136251
Oberling F, Cazenave JP, Lang JM, Kurtz D, Mayer G, Waitz R. [Apropos of certain toxic effects of L-asparaginase in human therapy]. Sem Hop 1971; 47: 1421-5. French. 4326093
Land VJ, Sutow WW, Fernbach DJ, Lane DM, Williams TE. Toxicity of L-asparginase in children with advanced leukemia. Cancer 1972; 30: 339-47. (Among 105 patients with leukemia treated with asparaginase, liver test abnormalities occurred in most patients and were fatal in two [fatty liver]). 4626307
Hasegawa Y, Suzuki T, Motegi F, Takanashi R. [Severe toxicity of L-asparaginase in the treatment of acute leukemia--the hepatocerebral lesions (author's transl)]. Rinsho Ketsueki 1973; 14: 917-24. Japanese. 4519904
Haghbin M, Tan CC, Clarkson BD, Miké V, Burchenal JH, Murphy ML. Intensive chemotherapy in children with acute lymphoblastic leukemia (L-2 protocol). Cancer 1974; 33: 1491-8. (Experience in treating 75 children with leukemia with intensive chemotherapy including asparaginase; two died of serum hepatitis from platelet transfusions; hepatotoxicity not discussed). 4526012
Rutter DA. Letter: Toxicity of asparaginases. Lancet 1975; 1 (7919): 1293-4. (Retrospective review of 77 courses of either E. coli or Erwinia carotovora derived asparaginase in patients with acute leukemia seen at 3 London hospitals, found slightly higher rates of side effects with E. coli product [liver injury not mentioned]; 10 patients with hypersensitivity reactions to one tolerated the other).
Olive D, Cartault F, Legras B, Neimann N. [Evaluation in children of the clinical, biological and electroencephalographic side effects of L-asparaginase]. Pediatrie 1976; 31: 259-78. French. 1069234
Woods WG, O'Leary M, Nesbit ME. Life-threatening neuropathy and hepatotoxicity in infants during induction therapy for acute lymphoblastic leukemia. J Pediatr 1981; 98: 642-5. (Two children [ages 16 and 14 months] developed neuropathy and hepatic failure during 4th week of chemotherapy with regimens including asparaginase for acute lymphocytic leukemia, with liver biopsies showing fat, focal necrosis and mild inflammation, one survived and one died of hepatic failure). 6937637
Haskell CM. L-Asparaginase: human toxicology and single agent activity in nonleukemic neoplasms. Cancer Treat Rep 1981; 65 Suppl 4: 57-9. (Unlike other antineoplastic agents, asparaginase has little bone marrow toxicity and its main side effects are on liver, kidneys, pancreas, central nervous and clotting system; hypersensitivity reactions can also occur and can be severe).
Cairo MS. Adverse reactions of L-asparaginase. Am J Pediatr Hematol Oncol 1982 Fall; 4: 335-9. (Review of toxicity of asparaginase; hepatic injury is most common and is marked by changes in AST, Alk P, bilirubin and albumin). 6959544
Distasio JA, Salazar AM, Nadji M, Durden DL. Glutaminase-free asparaginase from vibrio succinogenes: an antilymphoma enzyme lacking hepatotoxicity. Int J Cancer 1982; 30: 343-7. (Unlike standard, E coli-derived asparaginase, a glutaminase-free preparation did not cause hepatotoxicity or fatty liver in mice, suggesting that the hepatotoxicity of asparaginase is due to a contaminant). 6752048
Durden DL, Salazar AM, Distasio JA. Kinetic analysis of hepatotoxicity associated with antineoplastic asparaginases. Cancer Res 1983; 43: 1602-5. (Comparison of glutaminase-free and standard asparaginase in a mouse model found little hepatotoxicity, even with 3-4 weeks of therapy). 6339039
Kafkewitz D, Bendich A. Enzyme-induced asparagine and glutamine depletion and immune system function. Am J Clin Nutr 1983; 37: 1025-30. (Induced immune deficiency in mice given E. coli derived asparaginase was associated with decrease in glutamine, which did not occur with V. succinogenes derived product that is free of glutaminase). 6342356
Jenkins R, Perlin E. Severe hepatotoxicity from Escherichia coli L-asparaginase. J Natl Med Assoc 1987; 79: 775, 779. (51 year old woman with diabetes and acute lymphocytic leukemia developed jaundice at the end of a 10 day course of asparaginase [bilirubin 9.0 rising to 25.5 mg/dL, AST 344 to 1920 U/L, Alk P 400 to 1650 U/L, with high ammonia and decreased fibrinogen], but gradually improved and all tests were normal 4 months later).
Bessho F, Kinumaki H, Yokota S, Hayashi Y, Kobayashi M, Kamoshita S. Liver function studies in children with acute lymphocytic leukemia after cessation of therapy. Med Pediatr Oncol 1994; 23: 111-5. (Among 27 children with acute leukemia, serum ALT levels were often elevated during induction and maintenance therapy but were normal or near normal in all 3 months after stopping therapy and remained normal in long term follow up). 8202032
Wróbel G, Dobaczewski G, Kazanowska B, Boguslawska-Jaworska J, Balwierz W, Balcerska A, Bubala H, et al. [Adverse reactions associated with the use of L-asparaginase during therapy of patients with B non-Hodgkin's lymphoma. Report of the Polish Paediatric Leukaemia/Lymphoma Study Group]. Med Wieku Rozwoj 2000; 4: 67-72. Polish. (Abstract: among 66 children with non- Hodgkin lymphoma treated with asparaginase, 20 [30%] developed adverse reactions, mostly typically coagulation abnormalities [18%] and "impairment of liver function" [9%]).
Sahoo S, Hart J. Histopathological features of L-asparaginase-induced liver disease. Semin Liver Dis 2003; 23: 295-9. (Four patients developed hepatomegaly and abnormal liver tests 2-20 days after starting asparaginase [bilirubin 1.6-39.0 mg/dL, ALT 69-3916 U/L, Alk P 118-1075 U/L, albumin 2.2-2.6 g/dL] and had diffuse macro- and micro-vesicular steatosis on liver biopsy; one patient had acute liver failure and died). 14523682
Graham ML. Pegaspargase: a review of clinical studies. Adv Drug Deliv Rev 2003; 55: 1293-302. (Review of clinical trials of pegylated asparaginase; toxicities were similar to the standard product and included hypoalbuminemia, lipoprotein abnormalities and elevations in ALT, Alk P and bilirubin). 14499708
Bodmer M, Sulz M, Stadlmann S, Droll A, Terracciano L, Krähenbühl S. Fatal liver failure in an adult patient with acute lymphoblastic leukemia following treatment with L-asparaginase. Digestion 2006; 74: 28-32. (68 year old man developed jaundice after 26 days of chemotherapy which included asparaginase [bilirubin 10.9 rising to 32.2 mg/dL, ALT 122 rising to 526 U/L, Alk P 480 rising to 2688 U/L], with progressive somnolence, hyperammonemia, coagulopathy, coma and death from liver failure 4 weeks later: Case 1). 16988508
Flores-Calderón J, Exiga-Gonzaléz E, Morán-Villota S, Martín-Trejo J, Yamamoto-Nagano A. Acute pancreatitis in children with acute lymphoblastic leukemia treated with L-asparaginase. J Pediatr Hematol Oncol 2009; 31: 790-3. (Among 266 children given chemotherapy [including asparaginase with prednisone, vincristine, daunorubicin and methotrexate] for acute lymphocytic leukemia over a 6 year period, 18 [7%] developed pancreatitis arising 1-18 days after last dose of asparaginase [amylase 19-2893 U/L]; no fatalities, but 3 developed a pseudocyst and chronic symptoms and 3 required long term insulin). 19770681
Yong W, Zheng W, Zhu J, Zhang Y, Wang X, Xie Y, Lin N, et al. L-asparaginase in the treatment of refractory and relapsed extranodal NK/T-cell lymphoma, nasal type. Ann Hematol 2009; 88: 647-52. (Among 45 adult patients receiving asparaginase for refractory and relapsed NKT cell leukemia, side effects included elevations in ALT in 51%, bilirubin in 33% and decreases in albumin in 9%). 19107482
Ladas EJ, Kroll DJ, Oberlies NH, Cheng B, Ndao DH, Rheingold SR, Kelly KM. A randomized, controlled, double-blind, pilot study of milk thistle for the treatment of hepatotoxicity in childhood acute lymphoblastic leukemia (ALL). Cancer 2010; 116: 506-13. (Among 50 children with acute leukemia given maintenance chemotherapy [vincristine, mercaptopurine, methotrexate and prednisone] who had ALT elevations and who were treated with either milk thistle or placebo, there were few differences in subsequent ALT, AST and bilirubin levels, and elevations of serum ALT or AST above 5 times ULN occurred equally with or without milk thistle). 20014183
Raetz EA, Salzer WL. Tolerability and efficacy of L-asparaginase therapy in pediatric patients with acute lymphoblastic leukemia. J Pediatr Hematol Oncol 2010; 32: 554-63. (Review of safety and efficacy of asparaginase in children with ALL discusses hypersensitivity reactions and toxicity caused by inhibition of protein synthesis, which includes pancreatitis, thrombosis, and liver dysfunction, some degree of which occurs in most patients, with hepatic steatosis in 87% which often persists for months after discontinuation). 20724951
Tsutsui M, Koike M, Komatsu N. [Fulminant hepatitis possibly caused by L-asparaginase during induction chemotherapy in a patient with acute lymphoblastic leukemia]. Rinsho Ketsueki. 2012; 53: 531-4. Japanese. (44 year old man with ALL developed abnormal liver tests 10 days after starting asparaginase with progressive injury and death by day 32). 22728556
Okamura A, Nishimura M, Sanada Y, Yakushijin K, Matsuoka H, Yamamoto K, Minami H. L-Asparaginase-induced fulminating liver dysfunction. Int J Hematol 2013; 98: 6-7. (49 year old woman with ALL developed liver test abnormalities 20 days after starting therapy with CHOP and 5 doses of asparaginase [bilirubin 2.2 mg/dL, ALT 43 U/L, Alk P not given], with hepatomegaly and marked fatty liver by CT scan; recovery by day 100). 23702916
Roesmann A, Afify M, Panse J, Eisert A, Steitz J, Tolba RH. L-carnitine ameliorates L-asparaginase-induced acute liver toxicity in steatotic rat livers. Chemotherapy 2013; 59: 167-75. (Pretreatment with L-carnitine decreased the liver injury and steatosis of isolated perfused rat livers exposed to asparaginase). 24192517
Vetro C, Giulietti G, Calafiore V, Romano A, Di Raimondo F. A snapshot of asparaginase-induced liver insufficiency. Eur J Haematol 2014; 92: 271-2. (39 year old man with ALL and renal transplant developed hepatomegaly and marked fatty liver [by CT scan] 25 days after starting pegaspargase [bilirubin not given; AST 90 U/L, Alk P 167 U/L, albumin 2.3 g/dL, fibrinogen 0, antithrombin III 19%], with progressive liver failure and death). 24329712
Al-Nawakil C, Willems L, Mauprivez C, Laffy B, Benm'rad M, Tamburini J, Fontaine H, et al. Successful treatment of l-asparaginase-induced severe acute hepatotoxicity using mitochondrial cofactors. Leuk Lymphoma 2014; 55: 1670-4. (Three patients, ages 51 to 64 years, developed severe liver injury 11-22 days after starting asparaginase therapy for ALL [peak bilirubin 6.1-50.4 mg/dL, ALT 480-1150 U/L, Alk P 550-2400 U/L, CT scan showing hepatomegaly and fatty liver], all 3 recovering after L-carnitine and vitamin B therapy). 24090500
Saison J, Berger F, Lebosse F, Audoual R, Thomas X, Michallet M. Hepatomegaly and fever at the time of neutrophil recovery revealing L-asparaginase toxicity in the treatment of acute lymphoblastic leukemia. Am J Case Rep 2014; 15: 13-7. (52 year old man with ALL developed fever and hepatomegaly by day 25 of chemotherapy and, after 5 injections of asparaginase [bilirubin 7.5 mg/dL, ALT 148 U/L, Alk P 148 U/L], rising for 2 weeks and then returning to normal within 2 months, biopsy showing marked steatosis and mild necrosis). 24454976
Douer D, Aldoss I, Lunning MA, Burke PW, Ramezani L, Mark L, Vrona J, et al. Pharmacokinetics-based integration of multiple doses of intravenous pegaspargase in a pediatric regimen for adults with newly diagnosed acute lymphoblastic leukemia. J Clin Oncol 2014; 32: 905-11. (Among 51 adults with ALL treated with 192 doses of intravenous pegaspargase, ALT or AST elevations occurred in all patients [above 5 times ULN in 63%], and bilirubin in 26 patients [above 3 times ULN in 31%], but all resolved spontaneously [within 6-83 days], although therapy was delayed in 10 patients for high bilirubin and 11 for ALT or AST elevations). 24516026
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to asparaginase or pegaspargase). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [5%] were attributed to antineoplastic agents including 2 to asparaginase and 2 to pegaspargase, all 4 of which were jaundiced, but none were fatal). 25754159
Horvat TZ, Pecoraro JJ, Daley RJ, Buie LW, King AC, Rampal RK, Tallman MS, et al. The use of Erwinia asparaginase for adult patients with acute lymphoblastic leukemia after pegaspargase intolerance. Leuk Res 2016; 50: 17-20. (Ten adults with ALL with hypersensitivity or intolerance of pegaspargase were able to tolerate Erwinia asparaginase without hypersensitivity reactions and with only mild-to-moderate hepatotoxicity). 27631159
Göpel W, Schnetzke U, Hochhaus A, Scholl S. Functional acute liver failure after treatment with pegylated asparaginase in a patient with acute lymphoblastic leukemia: potential impact of plasmapheresis. Ann Hematol 2016; 95: 1899-901. (44 year old man with ALL developed liver failure 3 days after receiving pegaspargase [bilirubin rising to ~29 mg/dL, ALTto 2.5 times ULN, GGT to 16 times ULN], recovering over 3 week period following plasmapheresis). 27488287
Alshiekh-Nasany R, Douer D. L-Carnitine for treatment of pegasparaginase-induced hepatotoxicity. Acta Haematol 2016; 135: 208-10. (56 year old man with ALL developed jaundice after a single infusion of pegaspargase [peak bilirubin 26.6 mg/dL, ALT ~230 U/L, Alk P not given], resolving after a 6 day course of L-carnitine). 26841296
Hijiya N, van der Sluis IM. Asparaginase-associated toxicity in children with acute lymphoblastic leukemia. Leuk Lymphoma 2016; 57: 748-57. (Review of the mechanism of action of asparaginase and its toxicity in children). 26457414
Toksvang LN, De Pietri S, Nielsen SN, Nersting J, Albertsen BK, Wehner PS, Rosthøj S, et al. Hepatic sinusoidal obstruction syndrome during maintenance therapy of childhood acute lymphoblastic leukemia is associated with continuous asparaginase therapy and mercaptopurine metabolites. Pediatr Blood Cancer 2017; 64. e26519. (Among 130 children with ALL receiving a complex chemotherapy regimen that included 8-15 biweekly pegaspargase infusions, 29 developed liver injury diagnosed as sinusoidal obstruction syndrome [SOS] by clinical criteria alone, possibly due to asparaginase effects on mercaptopurine metabolism, but all children recovered).
Liu Y, Fernandez CA, Smith C, Yang W, Cheng C, Panetta JC, Kornegay N, et al. Genome-wide study links PNPLA3 variant with elevated hepatic transaminase after acute lymphoblastic leukemia therapy. Clin Pharmacol Ther 2017; 102: 131-40. (Testing of two cohorts of patients receiving asparaginase found associations of posttreatment ALT levels and the PNPLA3 variant that has been linked to ALT elevations in the general population and with alcoholic and nonalcoholic fatty liver disease). 28090653
Özdemir ZC, Turhan AB, Eren M, Bor Ö. Is N-acetylcysteine infusion an effective treatment option in L-asparaginase associated hepatotoxicity? Blood Res 2017; 52: 69-71. (2 year old with ALL developed liver test abnormalities after a fifth infusion of an E. coli derived asparaginase [bilirubin 7 mg/dL, ALT 501 U/L, Alk P 246 U/L, GGT 1297 U/L], with recovery after 6 days of N-acetylcysteine infusions and minimal hepatotoxicity with later chemotherapy using Erwinia asparaginase). 28401107
Blackman A, Boutin A, Shimanovsky A, Baker WJ, Forcello N. Levocarnitine and vitamin B complex for the treatment of pegaspargase-induced hepatotoxicity: A case report and review of the literature. J Oncol Pharm Pract 2018; 24: 393-7. (36 year old woman with ALL developed jaundice 4 days after a second dose of pegaspargase [days 4 and 17 of therapy] [bilirubin 11.5 mg/dL, ALT 2493 U/L, Alk P 270 U/L, INR 1.0], improving rapidly with L-carnitine [50 mg/k/day for 8 days] and vitamin B therapy and tolerating a reduced dose of pegaspargase, and resumption of chemotherapy with recurrence of liver injury 6 weeks later). 28523950
Burke PW, Aldoss I, Lunning MA, Devlin SM, Tallman MS, Pullarkat V, Mohrbacher AM, et al. Pegaspargase-related high-grade hepatotoxicity in a pediatric-inspired adult acute lymphoblastic leukemia regimen does not predict recurrent hepatotoxicity with subsequent doses. Leuk Res. 2018;66:49-56. (Among 51 adults with ALL treated with pegaspargase, 16 developed “high grade” hyperbilirubinemia and aminotransferase elevations, usually after the first dose, of whom 11 received another course of pegaspargase only 7 of whom had recurrence and none of whom died of hepatic failure). 29407583
Schulte RR, Madiwale MV, Flower A, Hochberg J, Burke MJ, McNeer JL, DuVall A, et al. Levocarnitine for asparaginase-induced hepatic injury: a multi-institutional case series and review of the literature. Leuk Lymphoma. 2018;59:2360-2368. (Among 6 children and young adults with ALL who developed liver injury with jaundice after chemotherapy with pegaspargase who were then treated with levocarnitine, the liver injury resolved in 5 but progressed to end-stage liver disease, pancreatitis and death in one). 29431566
Arora S, Klair J, Bellizzi AM, Tanaka T. L-carnitine and vitamin B complex for peg-L-asparaginase-induced hepatotoxicity. ACG Case Rep J. 2019;6:e00194. (A 58 year old woman with ALL developed evidence of liver injury 12 days after starting chemotherapy which included pegaspargase, and she was treated with levocarnitine with subsequent peak laboratory values of bilirubin 12.7 mg/dL, ALT 276 U/L and Alk P 1053 U/L, with ultimate complete resolution after which she tolerated chemotherapy using non-pegylated asparaginase). 31737724
Kamal N, Koh C, Samala N, Fontana RJ, Stolz A, Durazo F, Hayashi PH, et al.; Drug-Induced Liver Injury Network. Asparaginase-induced hepatotoxicity: rapid development of cholestasis and hepatic steatosis. Hepatol Int. 2019;13:641-648. (Among 1321 cases of confirmed drug induced liver injury enrolled in a U.S. prospective database between 2004 and 2017, 60 were due to cancer chemotherapeutic agents including 8 due to asparaginase [n=1] or pegaspargase [n=7], arising 9-21 days after starting therapy with initial and peak values of bilirubin 4.4 and 17.5 mg/dL, ALT 284 and 595 U/L, Alk P 159 and 785 U/L, all with low serum albumin levels [less than 2.0 g/dL], fatty liver by imaging, and ultimate complete resolution, one patient having similar but slightly milder injury upon re-exposure to pegaspargase). 31392570
Meunier L, Larrey D. Chemotherapy-associated steatohepatitis. Ann Hepatol. 2020;19:597-601. (Review of drug induced liver injury associated with steatosis or steatohepatitis including methotrexate, 5-fluorouracil, irinotecan, tamoxifen, and L-asparaginase which may be due to mitochondrial injury and can lead to chronic steatosis and cell injury). 32061473
Li RJ, Jin R, Liu C, Cao X, Manning ML, Di XM, Przepiorka D, et al. FDA approval summary: calaspargase pegol-mknl for treatment of acute lymphoblastic leukemia in children and young adults. Clin Cancer Res. 2020;26:328-331. (Summary of data on pharmacokinetics and safety that led to the FDA approval of calaspargase pegol as therapy of ALL in children and young adults [ages 1 month to 21 years] found that calaspargase and pegaspargase had similar patterns and rates of adverse events including ALT elevations above 5 times ULN in 52% vs 66%). 31444252
Lew G. Space for calaspargase? a new asparaginase for acute lymphoblastic leukemia. Clin Cancer Res. 2020;26:325-327. (Editorial in response to Li et al [2020] mentions that calaspargase has a longer half-life than standard pegaspargase and can be given every 3 weeks, but side effects and efficacy seem to be the same, and the role of calaspargase remains uncertain in the complicated regimens used to treat ALL in children). 31641006
Vrooman LM, Blonquist TM, Stevenson KE, Supko JG, Hunt SK, Cronholm SM, Koch V, et al. Efficacy and toxicity of pegaspargase and calaspargase pegol in childhood acute lymphoblastic leukemia: results of DFCI 11-001. J Clin Oncol. 2021;39:3496-3505. (Among 239 children or young adults [ages 1 month to 21 years] with ALL treated with calaspargase pegol every 3 weeks and pegaspargase every 2 weeks [2,500 IU/m^2^per dose] for 30 weeks, drug levels were similar as were rates of response [complete response in 95% vs 99%] and adverse events including hypersensitivity reactions and pancreatitis; no specific mention of ALT levels or hepatotoxicity]. 34228505
Schulte R, Hinson A, Huynh V, Breese EH, Pierro J, Rotz S, Mixon BA, et al. Levocarnitine for pegaspargase-induced hepatotoxicity in older children and young adults with acute lymphoblastic leukemia. Cancer Med. 2021;10:7551-7560. (Comparison of cohorts of pegaspargase treated patients with ALL who did [n=29] or did not [n=109] receive prophylaxis with levocarnitine in variable doses and routes of administration, demonstrated similar rates of hepatotoxicity with or without prophylaxis [14% vs 16%], although post-hoc adjustment for risk factors suggested a protective effect of levocarnitine). 34528411
Lee C, Leventhal TM, Anugwom CM. L-Asparaginase-induced hepatotoxicity treated successfully with L-carnitine and vitamin B infusion. Cureus. 2021;13:e16917. (69 year old woman with ALL developed evidence of liver injury and pancreatitis after receiving pegaspargase [bilirubin 2.0 rising to 7.6 mg/dL, ALT 72 to 142 U/L, Alk P 282 to 1170 U/L], with fatty liver by ultrasound and liver biopsy showing steatosis and canalicular cholestasis, with ultimate resolution having received a course of levocarnitine and vitamin B complex). 34513489
Defina M, Lazzarotto D, Guolo F, Minetto P, Fracchiolla NS, Giglio F, Forghieri F, et al. Levocarnitine supplementation for asparaginase-induced hepatotoxicity in adult acute lymphoblastic leukemia patients: A multicenter observational study of the campus all group. Leuk Res. 2022;122:106963. (Among 38 adults with ALL who developed asparaginase induced liver injury [33 with pegaspargase], onset was with the first course in 89% with a median latency of 11 [range 0 to 30] days and all received L-carnitine at a median of 2 [range 0 to 51] days after onset, resolving in a median of 14 [range 5 to 58] days, data that are similar to the literature on untreated asparaginase hepatotoxicity). 36155352
Wu S, Wang M, Alqahtani A, Lou M, Stock W, Bhojwani D, Alachkar H. Hispanic ethnicity and the rs4880 variant in SOD2 are associated with elevated liver enzymes and bilirubin levels in children receiving asparaginase-containing chemotherapy for acute lymphoblastic leukemia. Biomed Pharmacother. 2022;150:113000. (Among 143 children with ALL treated with asparaginase, hepatoxicity arose in 47% of Hispanic vs 33% of non-Hispanics, the Hispanic children being more likely to be overweight or obese [53% vs 44%] and more likely to have the CC genotype of rs4880 SNP of superoxide dismutase 2 [SOD2: 43% vs 15%]; in multivariate analysis, only Hispanic ethnicity was a significant risk factor for asparaginase hepatotoxicity). 35658244
Vetro C, Duminuco A, Gozzo L, Maugeri C, Parisi M, Brancati S, Longo L, et al. Pegylated asparaginase-induced liver injury: a case-based review and data from pharmacovigilance. J Clin Pharmacol. 2022;62: 1142-1150. (59 year old woman with ALL developed pancreatitis within a week of starting chemotherapy which included pegaspargase and which was followed by jaundice and progressive liver failure, lactic acidosis and death 37 days after starting chemotherapy). 35342960

## OTHER REFERENCE LINKS

Recent References on Asparaginase: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Asparaginase+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Asparaginase: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Asparaginase)

Recent References on Pegaspargase: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pegaspargase+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Pegaspargase: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pegaspargase)